# Saxagliptin

## OVERVIEW

### Introduction

Saxagliptin is a dipeptidyl peptidase-4 (DPP-4) inhibitor which is used in combination with diet and exercise in the therapy of type 2 diabetes, either alone or in combination with other oral hypoglycemic agents. Saxagliptin is a relatively new medication and has yet to be implicated in causing clinically apparent liver injury.

### Background

Saxagliptin (sax' a glip' tin) is an inhibitor of dipeptidyl peptidase-4, which is the major enzyme responsible for the degradation of glucagon-like peptide-1 (GLP-1), an important gastrointestinal hormone (incretin) that increases glucose dependent insulin secretion by the pancreas. By prolonging the effect of GLP-1, saxagliptin increases insulin levels and lowers blood glucose, thereby improving glycemic control in patients with type 2 diabetes. Saxagliptin was approved for use in the United States in 2009 and was the second DPP-4 inhibitor introduced into clinical practice. Its current indications are for management of glycemic control in type 2 diabetes used in combination with diet and exercise, with or without other oral hypoglycemic agents or insulin. Saxagliptin is available in tablets of 2.5 and 5 mg under the brand name Onglyza and as a fixed dose combination with metformin under the name Kombiglyze and with dapagliflozin under the name Qtern. The typical dose of saxagliptin in adults is 2.5 to 5 mg once daily. Adverse reactions to saxagliptin are not common, but may include headache, nausea, allergic reactions and rash. Hypoglycemia is uncommon with saxagliptin alone (<1%), but occurs in higher rates when it is combined with other oral hypoglycemic agents. Rare side effects reported with saxagliptin as with other DPP-4 inhibitors include bullous pemphigoid, severe arthralgias, acute pancreatitis and hypersensitivity reactions.

### Hepatotoxicity

In large clinical trials, rates of serum enzyme elevations were similar with saxagliptin therapy (<1%) as with placebo, and no instances of clinically apparent liver injury were reported. Nevertheless, postmarketing experience suggests that some DPP-4 inhibitors can cause hepatic enzyme elevations and rare instances of clinically apparent acute liver injury. However, instances of hepatotoxicity due to saxagliptin have yet to be published.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of possible liver injury during saxagliptin therapy is not known. The drug is metabolized by the liver, largely by the cytochrome P450 system (CYP 3A4), and a toxic or immunogenic intermediate of metabolism might be produced that could cause liver injury.

### Outcome and Management

The instances of liver injury associated with the DPP-4 inhibitors have been rare and self-limited, and have resolved rapidly and completely with stopping the medication. The similarity in activity among the DPP-4 inhibitors suggests that there may be cross sensitivity to hepatic injury among the different agents, but this has not been reported. However, the other common antidiabetic medications in use should be tolerated without increased risk of liver injury.

References regarding the hepatotoxicity and safety of the DPP-4 inhibitors are given in the Overview section of DPP-4 Inhibitors (updated 03 January 2018).

Drug Class: Antidiabetic Agents, Incretin-Based Drugs

Other Drugs in the Subclass, Dipeptidyl Peptidase-4 (DPP-4) Inhibitors: Alogliptin, Linagliptin, Sitagliptin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Saxagliptin – Onglyza®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Saxagliptin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Saxagliptin | 945667-22-1 | C18-H25-N3-O2.H2O | Saxagliptin Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Saxagliptin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Saxagliptin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Saxagliptin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Saxagliptin)